# Alfuzosin

## OVERVIEW

### Introduction

Alfuzosin is a nonselective alpha-1 adrenergic antagonist used in the therapy of benign prostatic hypertrophy. Alfuzosin is associated with a low rate of transient serum aminotransferase elevations and with rare instances of clinically apparent acute liver injury.

### Background

Alfuzosin (al fue' zoe sin) is an alpha-1 adrenergic antagonist approved for use in the United States for benign prostatic hypertrophy (but not for therapy of hypertension). Alfuzosin inhibits alpha adrenergic receptors present on smooth muscle in arterioles (called alpha-1b adrenergic receptors), as well as in those in the bladder neck and prostate (alpha-1a adrenergic receptors). The effects of the agent on smooth muscle of the bladder and prostate causes improvement in urine flow in men with partial obstruction due to benign prostatic hypertrophy. Alfuzosin was approved for use in the United States in 2003 for treatment of symptoms of urinary hesitancy due to benign prostatic hypertrophy. Alfuzosin is not approved for use in hypertension. Alfuzosin is available in extended release tablets of 10 mg in several generic forms and under the trade name Uroxatral. The recommended dose is 10 mg with the same meal once daily. Side effects include hypotension, dizziness and syncope (particularly with the initial dose), fatigue, headache, dizziness, palpitations, impotence, incontinence and gastrointestinal upset. Rare, but potentially severe adverse events include postural hypotension, worsening of angina pectoris, priapism and intraoperative floppy iris syndrome.

### Hepatotoxicity

Alfuzosin has been associated with a low rate of serum aminotransferase elevations (<2%) that in controlled trials was no higher than with placebo or comparative agent therapy. These elevations were transient and did not require dose modification. Since its approval and more wide spread use, several instances of clinically apparent acute liver injury due to alfuzosin have been published. The onset of injury was within 2 to 4 weeks and the pattern of enzyme elevations was predominantly hepatocellular. Prolonged jaundice with evolution to a cholestatic hepatitis was also described. Allergic features of rash, fever and eosinophilia can occur, but are usually not prominent. Autoantibodies are usually not found. Among the various alpha blockers used for hypertension or prostatic hypertrophy, alfuzosin has been most frequently associated with liver injury, but no instances of acute liver failure or vanishing bile duct syndrome have been described with it use.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations and rare instance of clinically apparent liver injury associated with alfuzosin use is not known. Alfuzosin is extensively metabolized by the liver by the cytochrome P450 enzymes (predominantly CYP 3A4) and generation of a mildly toxic intermediate is a possible explanation.

### Outcome and Management

No instances of acute liver failure or chronic liver injury have been reported in association with alfuzosin or other alpha-1 adrenergic blockers. There is no information on cross reactivity of the liver injury among the various alpha-1 adrenergic receptor antagonists, but similarity of chemical structure suggests that cross sensitivity may be present.

References to the safety and potential hepatotoxicity of alfuzosin are given in the Overview on the Alpha-1 Adrenergic Receptor Antagonists.

Drug Class: Benign Prostatic Hypertrophy Agents

Other Drugs in the Class:

- Alpha-1 Adrenergic Receptor Antagonists
  - Doxazosin, Silodosin, Tamsulosin, Terazosin
- 5-Alpha Reductase Inhibitors
  - Dutasteride, Finasteride

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alfuzosin – Generic, Uroxatral®

DRUG CLASS

Benign Prostatic Hypertrophy Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Alfuzosin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Alfuzosin | 81403-80-7 | C19-H27-N5-O4 | Alfuzosin Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Alfuzosin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Alfuzosin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Alfuzosin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Alfuzosin)